# Sevabertinib

## OVERVIEW

### Introduction

Sevabertinib is an oral kinase inhibitor that targets the human epidermal growth factor receptor 2 (HER2) and is used in the treatment of advanced non-small cell lung cancer with HER2 mutations. Sevabertinib is associated with a high rate of serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Sevabertinib (se va bur’ ti nib) is an orally available, small molecule, reversible inhibitor of the tyrosine kinase of the human epidermal growth factor receptor 2 (HER2, also known as ERBB2); it also has activity against the epidermal growth factor receptor (EGFR). HER2 is a cell surface receptor that regulates normal cell growth and is mutated or overexpressed in 2% to 4% of non-small cell lung cancers (NSCLC), an alteration associated with shorter survival and a greater risk of brain metastases. Sevabertinib blocks signaling through the mutated receptor, that results in inhibition of tumor cell growth. In an open label trial in patients with advanced HER2-mutant NSCLC, sevabertinib produced tumor responses in 38% to 71% of patients depending upon previous therapies, the responses lasting a median of 9 to 11 months. Sevabertinib was given accelerated approval in the United States in 2025 for the treatment of adults with locally advanced or metastatic non-squamous NSCLC bearing HER2 mutations. Sevabertinib is available in tablets of 10 mg under the brand name Hyrnuo. The usual adult dose is 20 mg twice daily, continued until the tumor progresses or side effects become unacceptable. Common side effects include diarrhea, rash, paronychia (nail bed infections), stomatitis (mouth sores), and nausea. Uncommon but potentially severe adverse events include severe diarrhea, liver injury, interstitial lung disease or pneumonitis, eye toxicity, pancreatic enzyme elevations, and embryo-fetal toxicity.

### Hepatotoxicity

Serum aminotransferase elevations are common during sevabertinib therapy, but clinically apparent liver injury has not been reported. Among 268 patients treated with the approved dose in the prelicensure trials, ALT elevations arose in 37% of patients which were above 5 times the upper limit of normal (ULN) in 2.3%. Bilirubin elevations occurred in 12% of patients and alkaline phosphatase in 22%, all of which were mild-to-moderate in degree. The elevations arose after a median of 1.4 months of therapy (range 0.2 to 14.5 months) and were generally transient and asymptomatic, resolving with dose interruption or reduction. Liver related adverse events led to temporary interruption of sevabertinib in approximately 4% of patients, dose reduction in 4%, and permanent discontinuation in less than 1%. Two patients had both ALT and bilirubin elevations , but on clinical review other causes of liver abnormalities were found, and neither case was judged to be due to sevabertinib. Because of the frequency of liver test abnormalities, the product label includes a warning about liver injury and recommends monitoring of liver tests before starting sevabertinib, every 2 weeks during the first month of therapy, and monthly thereafter. Sevabertinib has been in general use for a short time and its safety profile in larger populations has yet to be defined.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during sevabertinib therapy is not known. Sevabertinib is metabolized in the liver, largely by CYP 3A, and the injury may be due to a toxic or immunogenic intermediate. Sevabertinib is susceptible to drug-drug interactions with agents that affect CYP 3A activity; strong inhibitors raise its concentrations and should be avoided or accompanied by a reduction in dose, while moderate and strong inducers lower its concentrations and should also be avoided.

Drug Class: Antineoplastic Agents

Other HER2 Tyrosine Kinase Inhibitors: Lapatinib, Neratinib, Tucatinib, Zongertinib

### Outcome and Management

The serum aminotransferase elevations that arise during sevabertinib therapy are usually asymptomatic and resolve with temporary interruption or a reduction in dose, most patients being able to resume treatment. The product label recommends withholding sevabertinib for moderate or severe aminotransferase elevations that are not accompanied by a rise in bilirubin and resuming it at a lower dose once values improve, and stopping it permanently if aminotransferase elevations are accompanied by jaundice or symptoms. Whether there is cross sensitivity to liver injury among the several HER2 kinase inhibitors is not known.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sevabertinib – Hyrnuo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sevabertinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Sevabertinib | 2521285-05-0 (https://pubchem.ncbi.nlm.nih.gov/compound/155234713) | C24-H25-Cl-N4-O5 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 August 2026

Abbreviations: EGFR, epidermal growth factor receptor; HER2, human epidermal growth factor receptor 2, ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999, before the availability of the HER2 tyrosine kinase inhibitors such as sevabertinib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of the hepatotoxicity of cancer chemotherapeutic agents published in 2013; the HER2 tyrosine kinase inhibitors are not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/219972Orig1s000MultidisciplineR.pdf (Multidisciplinary FDA review of the data on safety and efficacy of sevabertinib that supported its accelerated approval as therapy of HER2-mutant non-small cell lung cancer (NSCLC); among the 268 patients given the approved dose, ALT elevations arose in 37% [and were above 5 times ULN in 2.3%], alkaline phosphatase in 22% and bilirubin in 12%. Two patients had concurrent ALT and bilirubin elevations, but on clinical review neither of them was judged to be due to sevabertinib).
Siegel F, Siegel S, Kotynkova K, Uzunbas G, Korr D, Tomono H, et al. Sevabertinib, a reversible HER2 inhibitor with activity in lung cancer. Cancer Discov 2025 Oct 15 (Epub ahead of print). PMID: (Description of the discovery and pre-clinical characterization of sevabertinib as a reversible inhibitor of mutated HER2 with antitumor activity in cell culture and animal models; effects on the liver were not reported). 41090369
Le X, Kim TM, Loong HH, Prelaj A, Goh BC, Li L, Fang Y, et al. Sevabertinib in advanced HER2-mutant non-small-cell lung cancer. N Engl J Med 2025; 393: 1819-32. PMID: (Among 209 patients with advanced HER2-mutant NSCLC treated with sevabertinib [20 mg twice daily] in an open label trial, tumor responses arose in 38% to 71% depending upon previous therapy, while ALT elevations arose in 14% of patients and were above 5 times ULN in approximately 2%, the elevations being largely transient and asymptomatic, and leading to permanent discontinuation in less than 1% without instances of jaundice or hepatic failure). 41104928
Sevabertinib (Hyrnuo) for NSCLC. Med Lett Drugs Ther 2026; 68: e34-5. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of sevabertinib shortly after its accelerated approval in the United States, lists hepatotoxicity as a potential severe adverse effect and recommends monitoring of liver tests before therapy, every 2 weeks for the first month, and monthly thereafter). 41649366
Keam SJ. Sevabertinib: first approval. Drugs. 2026;86:759-764. PMID: (Concise review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of sevabertinib shortly after its accelerated approval in the United States, mentions rare occurrences of marked elevations in serum ALT levels). 41882473

## OTHER REFERENCE LINKS

Recent References on Sevabertinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sevabertinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))

Trials on Sevabertinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sevabertinib)